# Phencyclidine

## OVERVIEW

### Introduction

Phencyclidine is an illegal, hallucinogenic drug that was initially used as an anesthetic agent in the 1950s and early 1960s, but was then withdrawn in 1965 because of dissociative hallucinogenic effects that were often disturbing and sometimes severe and prolonged. The “out-of-body” intense psychological and behavioral effects of low doses of phencyclidine led to its abuse. In the late 1960s and 1970s, phencyclidine (“angel dust”) became a widely used hallucinogenic drug. The effects were often extreme, marked by acute psychosis and aggressive and violent behaviors, and overdoses led to many emergency room visits and deaths from status epilepticus, hyperthermia, rhabdomyolysis and subsequent renal, respiratory and hepatic failure.

### Background

Phencyclidine (fen sye' kli deen) is an arylcyclohexylamine anesthetic that acts as a noncompetitive inhibitor of N-methyl-d-aspartate (NMDA) receptors in the brain. Phencyclidine infusions rapidly produce anesthesia and a unique cataleptic state with profound analgesia, unresponsiveness and amnesia, but often with maintenance of muscle tone, involuntary movements, open eyes and spontaneous breathing. The effect is called dissociative anesthesia, which can be associated with vivid hallucinations, agitation and delirium during emergence. These psychological and behavioral effects can be very disturbing, arise several hours after the anesthesia and persist for days. Because of these effects, phencyclidine (Sernyl) was withdrawn from human use in 1965. Phencyclidine continued to be available as a veterinary anesthetic (Sernylan), but was withdrawn from that use in 1978 in attempts to control its illicit availability. These same dissociative effects led to the recreational abuse of phencyclidine and for a period in the late 1960s and 1970s, phencyclidine (commonly known as “angel dust”) became a major drug of abuse. Phencyclidine taken by mouth or inhaled (smoked) in doses of 1 to 10 mg leads to rapid onset of euphoria and feelings of omnipotence, superhuman strength and social and sexual prowess. Use of phencyclidine chronically can be associated with severe violent and aggressive behavior and episodes of acute psychosis. Higher doses cause progressive confusion, disorientation, coma and seizures, and can lead to malignant hyperthermia, shock, rhabdomyolysis, renal failure and sudden death. In recent years, wider knowledge of its dangerous effects and the increasing limitation on its production have led to a decrease in the frequency (but not disappearance) of phencyclidine abuse. Attempts to modify the tertiary amine structure of phencyclidine to develop a safer and more useful anesthetic agent led to the development of ketamine, another anesthetic which has a similar mechanism of action as well as similar, although lesser, potential for abuse.

### Hepatotoxicity

Phencyclidine is no longer used medically and its production is outlawed. Nevertheless, phencyclidine remains an agent of abuse, used for its hallucinogenic effects. At low doses, phencyclidine appears to have little effect on the liver. However, high doses of phencyclidine have been associated with malignant hyperthermia which can trigger acute hepatitis necrosis and liver failure. Patients generally present with seizures and coma followed by severe hyperthermia, rhabdomyolysis and renal failure. The liver injury arises 1 to 2 days after the overdose with marked, rapid elevations in serum ALT, AST and LDH, with minimal increases in alkaline phosphatase and delayed rises in bilirubin (Case 1). Coma arises early along with prolongation of the prothrombin time, hyperammonemia and metabolic acidosis. The abnormalities resolve almost as rapidly as they develop and with suitable life support, survival is not uncommon (Case 1). The clinical syndrome is that of acute hepatic necrosis and resembles the acute liver injury that occurs with heat shock, severe hypoxia and hepatic ischemia. Liver biopsy shows severe centrilobular necrosis with mild inflammation.

Likelihood score: C[HD] (probable cause of clinically apparent acute liver injury but only when given in high doses).

Mechanism of Injury

The mechanism of acute liver injury by phencyclidine is probably hyperthermia, hypoxia and hypotension, and the clinical course and outcome resembles that associated with shock or severe hypoxia.

### Outcome and Management

Clinically apparent hepatobiliary injury associated with phencyclidine arises in the context of malignant hyperthermia, rhabdomyolysis and shock, usually the result of overdose which may be unintended and caused by the lack of reliability and control of drug concentration and purity in sources of this illicit agent. With adequate life support, recovery is generally rapid and complete.

Drug Class: Agents of Abuse; Anesthetics, General (withdrawn from market)

See also: Ketamine

## CASE REPORT

### Case 1. Hyperthermia followed by acute liver failure from phencyclidine overdose.

[Modified from case 3 in: Armen R, Kanel G, Reynolds T. Phencyclidine-induced malignant hyperthermia causing submassive liver necrosis. Am J Med 1984; 77: 167-72. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/6741977)]

A 25 year old man was arrested for bizarre behavior believed to be due to phencyclidine intoxication and developed severe agitation and hallucinations a few hours later. He was taken to a County hospital and found to have severe hyperthermia [108.4^o^F], tachycardia [160/min] and tachypnea [44/min]. He underwent intubation and mechanical ventilation and was treated with a cooling blanket and acetaminophen. His temperature fell but he remained in coma. Phencyclidine was detected in a gastric aspirate. Liver tests, which had been normal on admission, rose by day 2 to 3, with bilirubin rising from 0.7 to 22.5 mg/dL, ALT from 30 to above 9,000 U/L, and prothrombin index falling from 95% to 5% (Table). He remained in coma for 10 days, underwent emergency abdominal surgery on day 21 for a perforated duodenal ulcer, but then improved and was able to leave the hospital after 37 days. In follow up at 50 days, symptoms had resolved and all liver tests were normal or near normal.

#### Key Points

Medication: | Phencyclidine (unknown amount)
Pattern: | Hepatocellular
Severity: | 4+ (jaundice, hospitalization, coagulopathy)
Latency: | 1-2 days
Recovery: | Almost complete within 2 months
Other medications: | None mentioned

#### Laboratory Values

Days After Starting/Stopping | ALT (U/L) | Prothrombin Index (%) | CPK (U/L) | LDH (U/L) | Bilirubin (mg/dL) | Other
1 | 29 | 95% | 512 | 577 | 0.7 | Admission, creatinine 1.9
2 | >9,000 | 5% | 5,880 | 2,850 | 15.1 | Intubation
3 | 4,420 | 22% | 1,208 | 518 | 22.5
7 | 505 | 69% | 1,057 | 620 | 7.7
21 | 152 | 87% | 382 | 417 | 2.0 | Emergency surgery
50 | 79 | 103% | 28 | 411 | 0.8 | Outpatient visit
Normal Values | | <40 | >80% | <200 | <300 | <1.2

#### Comment

A young man was arrested for bizarre behavior suspected to be due to phencyclidine intoxication and became increasingly agitated, which led to hospital admission where he was found to have malignant hyperthermia. He promptly went into coma and required mechanical ventilation. The following day he was found to have severe hepatic injury as well. While serum bilirubin climbed from normal to 22.5 mg/dL within two days, other features of the liver injury began to improve rapidly. He developed an acute abdomen requiring emergency surgery for a perforated duodenal ulcer after 3 weeks in the hospital. A liver biopsy taken during surgery showed confluent centrizonal necrosis and cell dropout with minimal inflammation and no fibrosis, consistent with the clinical course of acute hepatic necrosis. Thus, the liver injury linked to phencyclidine overdose is more likely due to the hyperthermia caused by the drug rather than its direct toxic effect on hepatocytes.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Phencyclidine – Generic, Sernyl®

DRUG CLASS

Agents of Abuse

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Phencyclidine | 77-10-1 | C17-H25-N | Phencyclidine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 April 2016

Zimmerman HJ. Anesthetic agents. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 457-82. (Expert review of hepatotoxicity of anesthetic agents published in 1999, mentions that phencyclidine can cause hyperthermia, rhabdomyolysis, renal and liver failure accompanied by severe, centrizonal [zone 3] hepatic necrosis resembling injury that occurs with heatstroke).
Kenna JG. Mechanism, pathology, and clinical presentation of hepatoxicity of anesthetic agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 403-22. (Review of liver injury from anesthetic agents; does not discuss phencyclidine).
Patel PM, Patel HH, Roth DM. Ketamine. General anesthetics and therapeutic gases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 538-9. (Textbook of pharmacology and therapeutics).
Noguchi TT, Nakamura GR. Phencyclidine-related deaths in Los Angeles County, 1976. J Forensic Sci 1978; 23: 503-7. (Description of 5 fatal cases of phencyclidine overdose and 11 other deaths in which phencyclidine was contributory, often with a history of acute psychosis, several dying in drowning incidents). 744979
Thompson TN. Malignant hyperthermia from PCP. J Clin Psychiatry 1979; 40: 327. (31 year old man developed malignant hyperthermia [106.7 ^o^ F] 6 hours after ingesting phencyclidine with coma, seizures and subsequent renal failure requiring a 25 day hospitalization; no mention of ALT levels or liver injury). 457624
McCarron MM, Schulze BW, Thompson GA, Conder MC, Goetz WA. Acute phencyclidine intoxication: incidence of clinical findings in 1,000 cases. Ann Emerg Med 1981; 10: 237-42. (Among 1000 episodes of phencyclidine intoxication seen at a Los Angeles medical center, median age was 23 years [range 13-65 years], 88% were men; 57% had nystagmus, 57% hypertension, 37% acute brain syndrome, 11% unconscious, 35% violent behavior, 34% agitated, 19% hallucinating, 3.5% no behavioral changes, 30% tachycardia, 2.6% hyperthermia; among those tested, CPK was elevated in 70% and ALT in 50%, but none had accompanying bilirubin elevations). 7224271
Barton CH, Sterling ML, Vaziri ND. Phencyclidine intoxication: clinical experience in 27 cases confirmed by urine assay. Ann Emerg Med 1981; 10: 243-6. (Among 107 patients with phencyclidine intoxication, 27 were confirmed by urine testing including 20 men and 7 women, ages 17 to 30 years, often with hypertension, tachycardia and tachypnea, abnormal behavior [23: 85%], nystagmus [24: 89%], hospitalization [6: 22%], rhabdomyolysis [3: 11%] and renal failure [2: 7%], but no patient died). 7224272
Aniline O, Pitts FN Jr. Phencyclidine (PCP): a review and perspectives. Crit Rev Toxicol 1982; 10: 145-77. (Review of the clinical features and consequences of phencyclidine abuse, described as an “epidemic in urban North America”). 7044685
Armen R, Kanel G, Reynolds T. Phencyclidine-induced malignant hyperthermia causing submassive liver necrosis. Am J Med 1984; 77: 167-72. (Three young men with acute, severe phencyclidine intoxication, ages 21 to 32 years, were arrested for bizarre behavior and developed hyperthermia followed in 24 to 72 hours by acute liver and renal failure [bilirubin peak to 8.0 to 22.5 mg/dL, ALT >9000 U/L, Alk P not given, prothrombin index 5% to 22%], all ultimately recovering in 1-2 weeks: Case 1). 6741977
Patel R, Connor G. A review of thirty cases of rhabdomyolysis-associated acute renal failure among phencyclidine users. J Toxicol Clin Toxicol 1985-1986; 23: 547-56. (Description of 15 cases of rhabdomyolysis and renal failure after phencyclidine use seen at a Los Angeles hospital between 1979-84, and review of 15 cases from the literature including 28 males, 21 blacks, ages 17 to 46 years, 19 developing oliguria, 16 dialyzed, creatinine 2.3-18 mg/dL, 94% with myoglobin in urine and 3 dying of sepsis, status epilepticus and pulmonary embolism; no mention of ALT levels or liver injury). 3831378
Riordan SM, Williams R. Liver disease due to illicit substance use. Addict Biol 1998; 3: 47-53. (Review of the hepatotoxicity of illicit substances of abuse including amphetamines, MDMA [ecstasy], cocaine, heroin, LSD, and phencyclidine which, with overdoses, has been associated with hyperthermia induced acute hepatic necrosis). 26736079
Jentsch JD, Roth RH. The neuropsychopharmacology of phencyclidine: from NMDA receptor hypofunction to the dopamine hypothesis of schizophrenia. Neuropsychopharmacology 1999; 20: 201-25. (Review of the neurologic basis of phencyclidine effects and the possible role of glutamate neurotransmission through NMDA receptors in the pathogenesis of schizophrenia). 10063482
Mozayani A. Phencyclidine - Effects on Human Performance and Behavior. Forensic Sci Rev 2003; 15: 61-74. (Review of the chemistry, pharmacology, and mechanism of action of phencyclidine as well as the clinical features and management of intoxication). 26256594
Mozayani A, Schrode P, Carter J, Danielson TJ. A multiple drug fatality involving MK-801 (dizocilpine), a mimic of phencyclidine. Forensic Sci Int 2003; 133: 113-7. (45 year old man was found dead with an empty bottle of dizocilpine, an anticonvulsant and NMDA receptor antagonist similar to phencyclidine, autopsy did not show liver injury). 12742697
Carls KA, Ruehter VL. An evaluation of phencyclidine (PCP) psychosis: a retrospective analysis at a state facility. Am J Drug Alcohol Abuse 2006; 32: 673-8. (Among 20 patients with acute psychosis due to phencyclidine, the average hospitalization was for 4.1 [range 1-9] days compared to 13.6 [range 3-41] days for “functional” psychosis). 17127556
Bey T, Patel A. Phencyclidine intoxication and adverse effects: a clinical and pharmacological review of an illicit drug. Cal J Emerg Med 2007; 8: 9-14. (Review of the pharmacology, clinical effects, complications and management of phencyclidine intoxication and overdose). 20440387
deRoux SJ, Sgarlato A, Marker E. Phencyclidine: a 5-year retrospective review from the New York City Medical Examiner's Office. J Forensic Sci 2011; 56: 656-9. (Among 138 cases examined by the New York City Medical Examiner between 2003 and 2008 that tested positive for blood phencyclidine, 80 were considered violent deaths, but drug levels varied greatly suggesting that co-morbid conditions and mixed drug intoxications accounted for many of the deaths; no mention of liver failure). 21291469
Lodge D, Mercier MS. Ketamine and phencyclidine: the good, the bad and the unexpected. Br J Pharmacol 2015; 172: 4254-76. (History of the development of phencyclidine and its congener ketamine initially as anesthetic agents, but when found to cause dissociative states and hallucinations used as drugs of abuse. The identification of these anesthetics as antagonists of NDMA receptors in the CNS led to the hypothesis that schizophrenia was due to abnormalities of this glutamatergic neurotransmission pathways). 26075331

## OTHER REFERENCE LINKS

1. Recent References on Phencyclidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(zonisamide+AND+isoxazoles/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Phencyclidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=zonisamide)